# Hops

## OVERVIEW

### Introduction

Hop is an important agricultural plant that has been used to flavor beer for centuries and has been claimed to have sedative properties and to be useful for treatment of anxiety and insomnia. Hops have not been implicated in causing serum enzyme elevations or clinically apparent liver injury.

### Background

Hop (Humulus lupulus) is a perennial plant that is used largely as a flavoring in the production of beer. The hop plant is cultivated as a vine that grows around a physical support and produces shoots, heart shaped dark green leaves, fresh cones and flowers that are borne on lateral branches. The cones and flowers are used to prepare hops which have a distinctive bitter taste, attributed to lupulin, an aromatic acid. Other components of hops include several flavonoids, phenolic acid, volatile oils, tannins and resins. Besides its wide use as a flavoring agent for food and beer, hops is used as an ingredient in many creams and lotions. Extracts of hops have been used in oral herbal medications predominantly as a sedative for anxiety, tension and difficulty sleeping. While widely used, it has not been proven to be effective either as a sedative or hypnotic. Hops is found in multiple over-the-counter herbal mixtures in combination with other agents such as chamomile, passion flower and valerian, used as sleeping aids or mild sedatives. Side effects are few, but may include drowsiness, dizziness and hypersensitivity reactions.

### Hepatotoxicity

Despite, wide scale use, hops has not been convincingly linked to instances of clinically apparent liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Other Names: Asperge Sauvage, Couleuvree, Hopfenzapfen, Houblon, Lupulin, Pi Jiu Hua

Drug Class: Herbal and Dietary Supplements

See also Drug Class: Sedatives and Hypnotics, Herbals

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Hops – Generic (OTC Products)

DRUG CLASS

Herbal and Dietary Supplements

Sedatives and Hypnotics

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Hops)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Hops | 0977070679 | Unspecified | Add Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 30 March 2018

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbals are discussed, including comfrey, Jin Bu huan, germander, chaparral leaf, skullcap and valerian, but not hops).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS]; hops is not discussed).
Hops. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc., 2007: pp. 448-52. (Compilation of short monographs on herbal medications and dietary supplements).
Lindahl O, Lindwall L. Double blind study of a valerian preparation. Pharmacol Biochem Behav 1989; 32: 1065-6. (Controlled trial of valerian with lemon balm and hops vs lemon balm and hops alone in 27 subjects with sleep difficulties found better sleep quality with valerian; "no side effects were reported"). 2678162
Gyllenhaal C, Merritt SL, Peterson SD, Block KI, Gochenour T. Efficacy and safety of herbal stimulants and sedatives in sleep disorders. Sleep Med Rev 2000; 4: 229-51. (Review of herbals used for sleep disorders; mentions that animal studies suggest that hops has sedative effects, but there has been little clinical study of its efficacy in humans). 12531167
Morin CM, Koetter U, Bastien C, Ware JC, Wooten V. Valerian-hops combination and diphenhydramine for treating insomnia: a randomized placebo-controlled clinical trial. Sleep. 2005; 28: 1465-71. (Controlled trial of a valerian-hops combination vs diphenhydramine vs placebo in 184 patients with mild insomnia found a "modest hypnotic effect" for the herbal combination; there were no serious adverse events and side effects were similar between placebo and the herbals). 16335333
Wheatley D. Medicinal plants for insomnia: a review of their pharmacology, efficacy and tolerability. J Psychopharmacol 2005; 19: 414-21. (Review of herbals used to treat insomnia; the sedative effect of hops was suspected because of "Hop-picker fatigue", but a study in mice and a subsequent clinical trial in 15 humans found no evidence for sedative or sleep inducing effects). 15982998
Meolie AL, Rosen C, Kristo D, Kohrman M, Gooneratne N, Aguillard RN, Fayle R, et al.; Clinical Practice Review Committee; American Academy of Sleep Medicine. Oral nonprescription treatment for insomnia: an evaluation of products with limited evidence. J Clin Sleep Med 2005; 1: 173-87. (Systematic review of efficacy of nonprescription treatments for insomnia states that there is no scientific evidence in support of either safety or efficacy of hops in treatment of insomnia). 17561634
Salter S, Brownie S. Treating primary insomnia - the efficacy of valerian and hops. Aust Fam Physician 2010; 39: 433-7. (Systematic review of literature on efficacy of valerian and hops in treating insomnia; 9 studies of valerian alone and 3 of the combination of valerian and hops found some evidence of benefit of valerian, but the separate efficacy or role of hops could not be assessed; adverse events were not discussed). 20628685
Sarris J, Panossian A, Schweitzer I, Stough C, Scholey A. Herbal medicine for depression, anxiety and insomnia: a review of psychopharmacology and clinical evidence. Eur Neuropsychopharmacol 2011; 21: 841-60. (Systematic review and summary of clinical evidence of efficacy of herbals used to treat anxiety, depression and insomnia; mentions that hops has been studied in humans, but does not rank the herbal as having evidence for efficacy in insomnia in humans). 21601431
Drugs for insomnia. Treat Guidel Med Lett 2012; 10 (119): 57-60. (Guidelines for therapy of insomnia; mentions herbal products that are claimed to have sleep inducing effects including valerian root, kava, chamomile tea, passionflower, hops, lemon balm, lavender and skull cap, but that there is no convincing evidence for their efficacy and that the purity of commercially available over-the-counter products is suspect). 22777275
Bunchorntavakul C, Reddy KR. Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther 2013; 37: 3-17. (Review of HDS associated hepatotoxicity; does not mention hops). 23121117
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60:1399-408. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, none were attributed to hops). 25043597
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], none of which were due to hops: see Navarro [2014]). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Hops: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Hops/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Hops: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Hops)